# Cordyceps

## OVERVIEW

### Introduction

Cordyceps is the common name for several insect-parasitizing fungi, particularly Ophiocordyceps sinensis (formerly Cordyceps sinensis) and Cordyceps militaris. Extracts of these species of have been used in traditional Chinese medicine to treat multiple conditions including fatigue, aging, sexual dysfunction, and diabetes. Cordyceps extracts are generally well tolerated and have not been associated with serum aminotransferase elevations during therapy or with cases of clinically apparent acute liver injury.

### Background

Cordyceps is the common name for a parasitic fungus that typically infects insect or arthropod larvae and is native to the mountains of Southwest China and Tibet. Cordyceps extracts have been used in Chinese Traditional Medicine for over 1500 years to treat a wide spectrum of medical conditions including fatigue, aging, kidney disease, liver disease, heart disease, diabetes, colitis, and sexual dysfunction. There are more than 260 species of Cordyceps worldwide, the most used in herbal medicine being Cordyceps sinensis (now classified as Ophiocordyceps sinensis) and Cordyceps militaris. Laboratory studies suggest that cordyceps extracts have multiple biologic effects including antioxidant, antiinflammatory, antimicrobial, immunomodulatory, neuroprotective, cardioprotective, antidiabetic, and antineoplastic activities. Despite these findings in laboratory experiments and in animals, none of the purported beneficial effects of cordyceps have been demonstrated convincingly in clinical trials in humans. Cordyceps extracts contain multiple components including proteins, peptides, amino acids, polyamines, sugars, polysaccharides, mannitol, sterols, organic acids, ergosterol, fiber, vitamins, and minerals. Characteristically, these fungal extracts also contain multiple nucleosides as well as corycepin (3’-deoxyadenosine), corycepic acid, cordyheptapeptide A (a cycloheptapeptide), and bioxanthracenes. The constituents responsible for the purported biologic activities of cordyceps are not known. Furthermore, most commercial cordyceps supplements in current use are not derived from the natural fungus, but rather from a laboratory grown version referred to as Cordyceps sinensis-4 [Cs-4]. Because of its purported clinical effects, cordyceps is now found in multiple over the counter, commercial forms as capsules, tablets, powders, and beverages and are promoted for fatigue, aging, inflammation, hyperglycemia, and sexual dysfunction, or for boosting energy, athletic performance, immune reactivity, and for improving heart, kidney, liver, and metabolic function. Recommended doses of cordyceps in commercial products range from 0.5 to 4 grams daily. Cordyceps extracts are well tolerated and have only minimal or mild adverse events that can include abdominal discomfort, diarrhea, dry mouth, nausea, poor appetite, and rash.

### Hepatotoxicity

In multiple short- and long-term clinical trials of different preparations of cordyceps extracts, adverse side effects were described as uncommon and minimal with no mention of either hepatotoxicity or ALT elevations. Few prospective studies have included monitoring of liver tests, but those that did reported no change in serum aminotransferase levels. Despite widespread use, there have been no published reports of serum enzyme elevations or clinically apparent, acute liver injury attributed to cordyceps extracts.

A single case report in 2023 described an 81 year old woman on long term cordyceps therapy for irritable bowel syndrome who developed hepatoportal sclerosis, an uncommon chronic liver condition of unknown cause marked by portal hypertension, splenomegaly, thrombocytopenia and ascites. Serum bilirubin and aminotransferase levels were normal, but symptoms, and spleen size improved once the herbal supplement was discontinued. The absence of evidence of acute liver injury, the normal biochemical tests, and lack of other reports of this complication, make its association with cordyceps therapy uncertain.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which cordyceps might cause liver injury is unknown.

### Outcome and Management

Acute liver injury from extracts of cordyceps has not been reported. Cordyceps should be discontinued in patients who develop evidence of cirrhosis or portal hypertension.

Drug Class: Herbal and Dietary Supplements

Other common names: Aweto, Caterpillar fungus, Zombie fungus, Cs-4.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cordyceps – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cordycepin; (3’ Deoxyadenosine) | 73-03-0 | C10H13N5O3 | SID:403446915
Cordyheptapeptide A | CID 11542476 (https://pubchem.ncbi.nlm.nih.gov/compound/11542476) | C49H65N7O8

## ANNOTATED BIBLIOGRAPHY

References updated: 23 July 2026

Abbreviations: HDS, herbal and dietary supplements; Cs-4, Cordyceps sinensis-4.
Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not Cordyceps).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of Cordyceps).
https://en.wikipedia.org/wiki/Cordyceps (Wikipedia chapter on cordyceps mentions that it has been widely used in Traditional Chinese Medicine and while in vitro evaluation and animal studies and its chemical constituents suggest potential therapeutic applications, clinical studies have not demonstrated convincing effects in humans).
Parcell AC, Smith JM, Schulthies SS, Myrer JW, Fellingham G. Cordyceps sinensis (CordyMax Cs-4) supplementation does not improve endurance exercise performance. Int J Sport Nutr Exerc Metab. 2004;14:236-42. (Among 22 male cyclists treated with Cordyceps sinesis [Cs-4, 3 g] or placebo daily for 5 weeks, changes in oxidative capacity and endurance performance were similar in the two groups; no mention of adverse events or changes in serum aminotransferase levels). 15118196
Paterson RR. Cordyceps: a traditional Chinese medicine and another fungal therapeutic biofactory Phytochemistry. 2008;69:1469-95. (Extensive review of Cordyceps species, their classification, preparations, constituents, biologic activities, and purported medical uses; stresses the lack of clinical studies demonstrating the biologic effects in humans and need for future research). 18343466
Chen S, Li Z, Krochmal R, Abrazado M, Kim W, Cooper CB. Effect of Cs-4 (Cordyceps sinensis) on exercise performance in healthy older subjects: a double-blind, placebo-controlled trial. J Altern Complement Med. 2010;16:585-90. (Among 15 healthy adults, aged 50-75 years, treated with Cordyceps sinensis [Cs-4: 333 mg] or placebo three times daily for 12 weeks, changes in maximal oxygen uptake were similar in the two groups; no mention of adverse events or changes in serum aminotransferase levels). 20804368
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found no mention of cordyceps among a listing of agents with 5 or more adverse event reports). 19650152
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not cordyceps). 20949552
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs, and supplements, but did not list or mention cordyceps). 22928722
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the General population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population-based study of drug induced liver injury in Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing cordyceps). 23419359
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Systematic review of literature on HDS associated liver injury does not mention cordyceps). 23121117
Navarro VJ, Seeff LB. Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis 2013; 17: 715-35. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies). 24099027
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but no case was attributed specifically to cordyceps). 25043597
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107(Pt A): 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss cordyceps).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al.; Spanish DILI Registry. Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. 2018;16:1495-1502. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6]; cordyceps was not mentioned). 29307848
Jung SJ, Jung ES, Choi EK, Sin HS, Ha KC, Chae SW. Immunomodulatory effects of a mycelium extract of Cordyceps (Paecilomyces hepiali; CBG-CS-2): a randomized and double-blind clinical trial. BMC Complement Altern Med. 2019;19:77. (Among 79 adults treated with Cordyceps [1.68 g] or placebo daily for 8 weeks, natural killer [NK] cell activity increased with the herbal treatment but decreased slightly with placebo while serum levels of interleukins, gamma interferon and tumor necrosis factor-alpha did not change and there were no serious adverse events or discontinuations for side effects; no specific mention of serum aminotransferase levels). 30925876
Liao YH, Chao YC, Sim BY, Lin HM, Chen MT, Chen CY. Rhodiola/Cordyceps-based herbal supplement promotes endurance training-improved body composition but not oxidative stress and metabolic biomarkers: a preliminary randomized controlled study. Nutrients. 2019;11:2357. . (Among 14 young sedentary adults enrolled in an exercise training program and treated with a supplement containing Rhodiola crenulate and Cordyceps sinensis or placebo for 8 weeks, changes in maximal oxygen uptake and in serum glucose and insulin were similar in the two groups; no mention of adverse events or serum ALT or AST levels). 31623349
Kreipke VC, Moffatt RJ, Tanner CJ, Ormsbee MJ. Effects of concurrent training and a multi-ingredient performance supplement containing Rhodiola rosea and Cordyceps sinensis on body composition, performance, and health in active men. J Diet Suppl. 2021;18:597-613. (Among 21 college-aged men treated with an herbal supplement containing cordyceps or placebo for 14 weeks with concurrent exercise training, body strength improved and there were no overall differences in training performance between the two groups; no mention of adverse events or serum aminotransferase levels). 33078636
Tsai YS, Hsu JH, Lin DP, Chang HH, Chang WJ, Chen YL, Chen CC. Safety assessment of HEA-enriched Cordyceps cicadae mycelium: a randomized clinical trial. J Am Coll Nutr. 2021;40:127-132. (Among 49 healthy adults treated with Cordyceps cicadae extracts [1.05 g] enhanced with hydroxyethyl adenosine [HAE] daily for 3 months, serum ALT, AST, albumin, creatinine, cholesterol and triglyceride levels and complete blood counts did not change, and no adverse events were reported). 32702252
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62], and greater celandine [48]; cordyceps was not listed). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while cordyceps is not mentioned). 33434654
Kaur B, Vipani A, Trivedi H, Kuo A, Guindi M, Yang JD, Ayoub WS. Traditional Chinese Medicine, Cordyceps, related to hepatoportal sclerosis. ACG Case Rep J. 2023;10:e01206. (81 year old woman developed abdominal pain and weight loss and was found to have liver disease [bilirubin 0.7 mg/dL, ALT 26 U/L, Alk P 72 U/L, platelet count 76,000/uL] with splenomegaly, small esophageal varices, and a liver biopsy showing hepatoportal sclerosis, clinical features improving with stopping cordyceps which she had used for 5 years for irritable bowel syndrome). 38033616
Nakamura A, Shinozaki E, Suzuki Y, Santa K, Kumazawa Y, Kobayashi F, Nagaoka I, et al. Effect of the administration of Cordyceps militaris mycelium extract on blood markers for anemia in long-distance runners. Nutrients. 2024;16:1835. . (Among 22 healthy long-distance male runners treated with a Cordyceps militaris extract [1800 mg] or placebo daily during 8 weeks of a pre-season training period, blood counts and serum levels of ALT, AST and creatinine did not change in either group). 38931190
Ontawong A, Pengnet S, Thim-Uam A, Munkong N, Narkprasom N, Narkprasom K, Kuntakhut K, et al. A randomized controlled clinical trial examining the effects of Cordyceps militaris beverage on the immune response in healthy adults. Sci Rep. 2024;14:7994. . (Among 20 healthy adults given a fermented Cordyceps militaris or placebo beverage once daily for 8 weeks, complete blood counts, serum ALT and AST and immunoglobulin levels did not change in either group; adverse events were not reported). 38580687
Sadowska A, Włosek-Pawełas D, Car H. Medicinal mushrooms and their bioactive compounds: from traditional use to therapeutic potential. Molecules. 2026;31:1749. (Among the millions of species of fungi worldwide, about 2000 are edible, and 200 are recognized as having medicinal properties such as antineoplastic, antidiabetic, anti-inflammatory, antioxidant, antiviral, cardioprotective, neuroprotective, and immunomodulatory activities, the best-known medicinal mushrooms being red yeast rice, lingzhi, and Cordyceps sinensis and militaris; no mention of ALT elevations or hepatic adverse effects). 42197308

## OTHER REFERENCE LINKS

1. Recent References on Cordyceps: from PubMed.gov (https://pubmed.ncbi.nlm.nih.gov/?term=Cordyceps)

2. Trials on Cordyceps : from ClinicalTrials.gov (https://clinicaltrials.gov/search?term=cordyceps&viewType=Table)